# Roussel Uclaf Causality Assessment Method (RUCAM) in Drug Induced Liver Injury

RUCAM Worksheet (PDF – 135 KB)

## Manual of Operations

Introduction. The RUCAM system is a means of assigning points for clinical, biochemical, serologic and radiologic features of liver injury which gives an overall assessment score that reflects the likelihood that the hepatic injury is due to a specific medication. Introduced in 1993, RUCAM is now widely used in assessing causality of drug induced liver injury, both in the published literature and in support of regulatory decisions regarding medications implicated in causing hepatic injury. RUCAM has been evaluated for accuracy, reproducibility and intraobserver variability and has performed moderately well. Because the RUCAM score is based upon objective measurements, however, there actually should be little or no variation in the final scores by different investigators. The variation that does occur is likely due to the ambiguity of some of the descriptions in how to assign individual scores, and variation in interpretation and understanding of how scores are assigned. In an attempt to standardize and improve the reliability of the RUCAM system, this Manual of Operations was written with the hope of minimizing variability among ratings and eventually reaching a consensus on how the individual scores of the RUCAM are obtained.

Background. The RUCAM is calculated for each implicated medication, a separate RUCAM score being given for each agent that is considered. The total score consists of points for 8 separate factors in 7 categories that help define the “signature” of the drug induced liver injury. These factors are: (1) time to onset (+1 or +2); (2) course (-2, 0, +1, +2 or +3); (3) risk factors (2 scores: 0 or +1 each); (4) concomitant drugs (0, -1, -2 or -3); (5) nondrug causes of liver injury (-3, -2, 0, +1, or +2); (6) previous information on the hepatotoxicity of the drug (0, +1, or +2); and (7) response to rechallenge (-2, 0, +1, or +3). The individual points range from -3 to +3 and the total possible score ranges from -9 to +14. Scores at or near the extremes of this range are rare. The interpretation of the final score is as follows: 0 or less indicate that the drug is “excluded” as a cause; 1 to 2 that it is “unlikely”; 3 to 5 “possible”; 6 to 8 “probable”; and greater than 8, “highly probable”. When comparing RUCAM to other causality assessment instruments, other terms are sometimes used for “highly probable”, including “highly likely” and “definite.”

While the total range of the RUCAM is -9 to +14, it should be stressed that without readministration or rechallenge, the total range is actually -7 to +11. Furthermore, 2 points are allocated for special risk factors, and if a patient is not alcoholic, pregnant or above the age of 55 years, the total range of possible RUCAM scores is only -7 to +9. Finally, for cholestatic and mixed injury, the range of scores for the course of the reaction is more limited (0 to +2, rather that -2 to +3), so that the range (in the absence of rechallenge, alcohol, pregnancy or age above 55 years) is only -5 to +8. Thus, in many instances, only a “probable” rating can be assigned. Indeed, in many cases of typical augmentin induced cholestatic hepatitis, the maximum score is only 7, because the onset is typically after the drug is stopped.

Step One. Calculation of the R Ratio. The initial step in the RUCAM assessment is to define whether the hepatic injury is “hepatocellular”, “mixed”, or “cholestatic.” These terms refer to the pattern of serum enzyme elevations at disease onset and not to clinical features or liver biopsy findings. The terms are defined by calculation of the “R ratio”.

The R ratio is calculated by dividing the alanine aminotransferase (ALT) by the alkaline phosphatase (Alk P), using multiples of the upper limit of the normal range for both values. The values used should be from the same day (or no more than 2 days apart) and should be those from the initial blood test results following onset of liver injury. Local normal ranges should be used to calculate the fold increase above the upper limit of the normal range (ULN).

R = ( A L T v a l u e ÷ A L T U L N ) ÷ ( A l k P v a l u e ÷ A l k P U L N )

R ratios of >5 define a hepatocellular, <2 a cholestatic, and between 2 and 5 a mixed pattern of enzymes. If the ALT value is more than twice the upper limit of the normal range (ULN) and the Alk P is normal, the pattern should be considered hepatocellular and an R ratio need not be calculated. Similarly, if the Alk P value is more than twice ULN but the ALT is normal, the pattern should be considered cholestatic, and an R ratio need not be calculated.

In the RUCAM system, cases that are mixed are given scores as if they were cholestatic.

Problems in calculating the R ratio. Five special problems arise in calculating the R ratio.

1. The timing of the blood test is critical in defining the pattern of serum enzyme elevations accurately. In some instances, an enzyme pattern that was initially hepatocellular can evolve into a mixed or even cholestatic pattern. Blood samples that are taken very early in the course of injury are more likely to show a hepatocellular pattern of injury; samples taken late in the course of an icteric case of drug induced liver injury are more likely to show a cholestatic pattern. Thus, in the literature, many cases of prolonged drug induced liver injury are called “cholestatic” even though the initial enzyme elevations were hepatocellular in pattern.

Recommendation: For the RUCAM, the values used to calculate the R ratio should be the first values obtained that qualify as being indicative of drug induced liver injury (usually when ALT or Alk P rises above 2 times the ULN or bilirubin above 2.5 mg/dL in association with enzyme elevations).

2. The Alk P may be elevated for nonhepatic reasons such as bone disease, cancer or pregnancy. Furthermore, normal levels of Alk P are higher in children than in adults and the normal range varies by age. Finally, Alk P levels may not be available.

Recommendation: In children or in clinical situations where it is suspected that Alk P elevations are from an extrahepatic source, the gamma glutamyl transpeptidase (GGT) level can be used if available, but the accuracy of using GGT as a substitute for Alk P in calculating the R ratio has yet to be shown and deserves future evaluation.

3. In some situations only AST and not ALT values are available.

Recommendation: The AST can replace the ALT values in calculation of the R ratio, but the validity of this substitution has yet to be shown and deserves future evaluation.

4. The use of ULN to calculate the R ratio can be problematic, because the ULN may vary from laboratory to laboratory and criteria for a normal ALT level remain unclear. A typical ULN for ALT is 40 or 42 U/L, but in some laboratories the ALT ULN is 55 U/L or even 66 U/L. Furthermore, studies done on normal populations suggest that the ULN for ALT varies by age and gender and should be 33 U/L for men and 19 U/L for women.

Recommendation: Until the uncertainties of the proper ULN values are resolved, the local ULN should be used to calculate the R ratio. If values are not provided, the ULN should be considered 40 U/L for ALT and 115 U/L for Alk P.

5. RUCAM does not provide instructions on how to assign an R ratio in patients with preexisting liver disease or abnormal serum enzyme levels before the medication is started. Between 5% and 20% of the normal population may have preexisting liver disease or abnormal serum enzymes, making this a common problem.

Recommendation: A reasonable approach in this situation is to use the preexisting average levels of ALT or Alk P as a upper limit of normal to calculate the R ratio. In this situation, however, both values must be calculated in the same manner.

Step Two. Calculation of the RUCAM Score. Once the enzyme pattern has defined an R ratio and the type of injury, a RUCAM score can be calculated. The criteria for scoring the first 3 of the 7 categories is determined by the R ratio.

1. Time to Onset. The first scores are given on the basis of time to onset or the “latency” of the hepatic injury, a very important factor in the “signature” of drug induced liver disease. The time to onset should be calculated from the first day (day 0) that the medication was given to the day of onset of the first symptom, sign or laboratory test abnormality indicative of the drug induced liver injury (whichever is first). If the onset of injury is before starting the drug, the injury is considered “unrelated” and a RUCAM should not be calculated. If the onset of injury is more than 15 days after stopping the drug in instances of hepatocellular injury, or more than 30 days after stopping in instances of mixed or cholestatic injury, the injury should be considered “unrelated” and the RUCAM should not be calculated. An exception to these rules is for drugs that are slowly metabolized, although the RUCAM system does not define what is meant by drugs that are slowly metabolized or how much of an exception should be made. The following agents typically cause a delayed hepatic injury that can arise more than 30 days after stopping therapy: amiodarone, leflunomide, and clavulanate. Finally, when the time to onset is unknown, the case should be considered “insufficiently documented” in which case a RUCAM cannot be calculated. In instances where the exact date of first exposure is not known, the date should be estimated if within a week in instances with a time to onset of >15 to <90 days; for cases with an onset of greater than 90 days, the exact day of starting the medication is unlikely to alter the scoring, but the month of starting should be known.

Cases are then assigned scores for time to onset based upon the type of injury (R value), whether the treatment medication was given for the first time, and whether the onset is during therapy or occurs after the medication is stopped. Patients with hepatocellular injury (R >5) receiving the medication for the first time are given 2 points if the time to onset is 5 to 90 days and they are still receiving the medication, but only 1 point if the time to onset is less than 5 or more than 90 days. Patients with hepatocellular injury who had received the medication previously are given 2 points if the time to onset is 1 to 15 days, but only 1 point if it is greater than 15 days. Patients with hepatocellular injury who have the onset of injury after stopping the medication are given 1 point if the onset is within 15 days of stopping, whether or not the drug is given for the first time. If the onset of hepatocellular injury is more than 15 days after stopping the medication, the injury should be considered “unrelated” and the RUCAM should not be calculated.

Patients with mixed or cholestatic injury who are receiving the medication for the first time are given 2 points if the time to onset is 5 to 90 days and they are still receiving the medication, but only 1 point if the time to onset is less than 5 or more than 90 days (these criteria are the same for hepatocellular injury). Patients with mixed or cholestatic injury who have received the medication in the past are given 2 points if the time to onset is 1 to 90 days, but only 1 point if more than 90 days. Among patients with mixed or cholestatic injury who develop hepatic injury after stopping therapy, 1 point is given if the time to onset is 30 days or less regardless of whether they are receiving the medication for the first or subsequent times. If the onset of mixed or cholestatic injury occurs more than 30 days after stopping the medication, the injury should be considered “unrelated” and the RUCAM should not be calculated.

Only one score is given under the category of time to onset. Thus, if the onset of injury occurs within 15 days after stopping the medication but also within 90 days of starting, one does not give 1 point for the fact that its onset was within 15 days after stopping and 2 points because it was within 90 days of starting. Rather, one gives the case 1 point only, because the onset of injury occurred after the drug was stopped. Thus, the only two scores possible under time to onset are 1+ (compatible) or 2+ (suggestive). There is no option to give a score of 0.

2. Course. The second category of scoring in the RUCAM system is for the subsequent course of illness. For most patients, the medication is stopped and there is at least some documentation of subsequent improvement or lack thereof. If the drug is continued, no score (0) is given in this category. If the medication is stopped and there is rapid improvement, scores are given based upon the speed and degree of improvement, scores being assigned differently among patients with hepatocellular injury than among those with mixed or cholestatic injury.

For patients with hepatocellular injury, 3 points are given if the ALT falls by 50% from the peak value within 8 days (“highly suggestive”), and 2 points are given if the ALT falls from its peak values by 50% within 30 days (“suggestive”). No points are given if there is no information about the course of ALT values or if there is a 50% decrease, but it occurs after 30 days. Importantly, -2 points are assigned if the ALT does not decrease by more than 50% or if there is a recurrent increase.

Several provisos need to be made about these calculations.

Often the timing of the decrease is not completely clear, such as if the ALT is not tested during the first 8 days but has decreased by more than 50% when first tested at 10 or 14 days. Similarly, the ALT may not have been tested between day 8 and 30, but is found to have fallen by more than 50% shortly after day 30. In these situations, the slope of the fall over time can be calculated and extrapolated to day 8 or day 30. However, another approach is to use whatever time frame is available, which would provide a more conservative estimate. In any case, adequate follow up is needed to demonstrate whether or not there is a decrease in ALT. Thus, the RUCAM requires 30 days of follow up for cases of hepatocellular injury.

The percent fall of ALT is calculated based upon the peak value, not the value at the time that the medication was stopped. Thus, in some instances, ALT values continue to increase for several days or even a few weeks after the medication is stopped. In these circumstances, the peak value obtained is used to calculate the percent decrease and the time to 50% decrease.

In addition, the percent decrease is calculated based on the amount in excess of the upper limit of normal. It is easiest to use the multiples of the ULN to calculate the percent decrease:

P e r c e n t d e c r e a s e = 100 % × ([ ( A L T p e a k / U L N ) - ( A L T v a l u e / U L N ) ])/([ ( A L T p e a k / U L N ) - 1 ) ])

Thus, when a normal ALT is 40 U/L, a fall in ALT from 250 U/L to 36 U/L is from 6.3 to 0.9 times ULN and is a 100% decrease (100% times [6.3-0.9]/[6.3-1.0]). A fall in ALT from 250 U/L to 130 U/L is from 6.3 to 3.3 time ULN and represents is a 57% decrease (100% times [5.3-2.3]/[5.3-1.0]).

In cases of acute liver failure leading rapidly to death or liver transplantation, the course of ALT elevations may not be available or may be unreliable. In this and many other ways, assessing causality in acute liver failure is very difficult.

Only one score is given for the course of illness in the RUCAM system and for patients with hepatocellular injury; the score can range from -2, 0, +1, +2, or +3.

For patients with mixed or cholestatic injury, 2 points are given if the Alk P or total serum bilirubin falls by more than 50% from the peak value within 180 days. One point is given if the Alk P or bilirubin decrease, but by less than 50% within 180 days. No points are given in other situations, such as persistence of the abnormalities or recurrent increases. Thus, the possible scores for cholestatic and mixed injury are only 0, +1 or +2, which is a more limited range than for hepatocellular injury (which can range from -2 to +3).

Several points need to be made about these calculations which parallel those made for calculations of the RUCAM score for course of illness of patients with hepatocellular injury.

Often, the timing of the decrease is not completely clear; thus, the Alk P or total bilirubin may not have been tested very frequently, but is first found to have decreased by 50% when tested shortly after 180 days. In these situations, the slope of the fall over time can be calculated and extrapolated to day 180. However, another approach is to use whatever time frame is available, providing a more conservative estimate. Obviously, adequate follow up is needed to demonstrate whether or not there is a decrease in Alk P or bilirubin. Thus, the RUCAM requires 180 days of follow up for cases of cholestatic injury.

The percent falls of Alk P and total bilirubin are calculated based upon the peak values, not the values at the time that the medication was stopped. Thus, in some instances, Alk P and total bilirubin values continue to increase for several days or even weeks after the medication is stopped. In these situations, the peak value obtained is used to calculate the percent decrease.

The percent decrease is calculated based on the peak value and the upper limit of normal using the same formula as given for ALT.

Thus, a fall from an Alk P of 350 U/L to 100 U/L (where 115 U/L is normal) is a 100% decrease. A decrease from 350 U/L to 150 U/L is an 85% decrease. In the case of total bilirubin, a value of 1.0 mg/dL (or 17.1 μmol/L) should be used as the normal level in the calculation.

The scoring for the course of illness can use either the Alk P or total bilirubin level. In situations in which both are substantially raised and both are available, the Alk P should be used. The total bilirubin should be used if the Alk P is normal or minimally elevated (less than twice the upper limit of the normal range), and particularly if total bilirubin is above 10 mg/dL (170 μmol/L).

Only one score is given for the course of illness in the RUCAM system, and for patients with a mixed and cholestatic pattern of injury, the scores are limited to 0, 1+ and 2+. Patients with these patterns of injury do not qualify for +3 points in this category, but also are not penalized -2 points for lack of improvement, even after 180 days.

Several other difficulties may arise in calculating the course of enzyme elevations. Thus, the ALT or Alk P may have been abnormal before the medication was taken due to an underlying liver disease, in which situation the percent decrease to normal should be replaced by percent decrease to preexisting levels. In addition, the Alk P may be elevated for other reasons (pregnancy, growth, bone disease), in which case the bilirubin should be used or possibly GGT. Finally, the criteria for “<50% decrease” versus “persistence or increase” are not well defined. A compromise would be that a <50% decrease need be at least 20%, and otherwise be considered “persistence”.

3. Risk Factors. Points are given for risk factors also according to the pattern or type of injury. Patients with hepatocellular injury are given 1 point for a history of alcohol use and 1 point if they are 55 years of age or older, for a possible total of 2 points. Patients with cholestatic or mixed injury are given 1 point for a history of alcohol use or pregnancy (not both: only 1 point can be given) and 1 point if they are 55 years of age or older, for a possible total of 2 points. Alcohol use is not defined in the RUCAM system. A reasonable approach is to define alcohol use as ingesting at least 20 grams (2 drinks) of ethanol per day for women and 30 grams (3 drinks) per day for men during at least part of the time that the medication was used. Similarly, pregnancy might be defined as being pregnant within 90 days of onset of hepatic injury. Points are not given for minimal alcohol use, or a distant history of excessive alcohol use or previous pregnancies. The age is calculated based upon the age in years at the time of onset of hepatic injury.

4. Concomitant Drug(s). The fourth category of points assigned in the RUCAM system is based upon whether other drugs or potential hepatotoxins were used. For this category, points are given regardless of whether the injury is hepatocellular, mixed or cholestatic. These points are largely negative and reflect the likelihood of contribution of the other agent to the hepatic injury, assessed based upon the time to onset of injury. No points are given if no other medications were taken or if another agent (even a known hepatotoxin) was taken, but with an incompatible time to onset (such as after the onset of injury or continuously for many years in agents associated with a defined latency). A minus one (-1) point is assigned if a drug was given that is not known to cause liver injury, but with a compatible or suggestive time to onset. Minus two (-2) points are assigned if a drug known to cause liver injury was given and the time to onset was compatible or suggestive of its role in injury. Minus three (-3) points are subtracted if the agent has further evidence for causing the injury in the form of a positive rechallenge or a validated biomarker test. The last score is rarely assigned.

Several issues require clarification in assigning points in this category.

An incompatible time to onset is not well defined. For instance, some agents typically have a latency of several years (methotrexate, amiodarone, nitrofurantoin), while others rarely have a latency above a few weeks (sulfonamides, quinolones).

Drugs that are capable of causing liver injury are not defined. Thus, many agents are very rare causes of hepatoxicity (penicillin or aminoglycosides for instance), yet case reports of injury from them have been reported. Actually, there are few medications that have never been linked to liver injury.

It is not clear what a compatible or suggestive time to onset would be for a concomitant drug with little or no hepatotoxic potential. If one uses the definitions of compatible or suggestive time frames given in category 1, the time to onset could be virtually any duration of therapy (compatible is <5 or >90 days), as long as the injury had its onset with 15 days of stopping (for hepatocellular) or 30 days of stopping therapy (for cholestatic or mixed injury). A reasonable compromise is to use 5 to 90 days as suggestive or compatible for agents not known to cause liver injury and to use the accepted latency of injury for agents known to be hepatotoxins.

Finally, the categorization ignores the variation in clinical presentation of different types of hepatotoxicity. Thus, the latency associated with amiodarone and nitrofurantoin is quite different from the sulfonamides, macrolides or penicillins.

For these reasons, this score is often based on a subjective interpretation of the likelihood that another agent taken might have caused the injury.

5. Search for Non-Drug Causes. The fifth category in the RUCAM system assigns points for the degree to which other causes of liver diseases have been excluded, the diagnoses being separated into Group I (viral hepatitis A, B and C, biliary obstruction, alcoholic liver disease, and ischemic hepatitis) and Group II (complications of underlying diseases or conditions). For this category also, points are given regardless of whether the injury is hepatocellular, mixed or cholestatic. A total of 2 points are assigned if all causes in Groups I and II are reasonably ruled out; 1 point if all 6 causes in Group I are ruled out, but not those of Group II; 0 points if only 4 or 5 causes in Group I are ruled out; -2 points if fewer than 4 causes in Group I are ruled out; and -3 points if another liver disease appears to be “highly probable”.

The diagnostic criteria to rule out other liver diseases are not well defined in the RUCAM form.

The following criteria are appropriate for Group I:

- Acute hepatitis A. Absence of anti-HAV or IgM anti-HAV
- Acute hepatitis B. Absence of anti-HBc or IgM anti-HBc
- Acute hepatitis C. Absence of HCV RNA or anti-HCV (if tested in convalescence)
- Biliary obstruction. Liver imaging (ultrasound, CT, ERCP, or MR) showing no evidence of biliary dilatation
- Alcoholic liver disease. Absence of history of excessive alcohol use (defined above) and ratio of AST/ALT values of less than 2.0
- Ischemic hepatitis. No history or likelihood of episode of shock, hypoxia or heart failure within 2 weeks of onset of liver injury.

Excluding other causes under Group II is based largely on clinical presentation and history. However, the other causes are not defined and several other conditions are important to exclude before making the diagnosis of drug induced liver injury. The RUCAM form includes CMV, EBV or herpes virus infections, but these are rare causes of liver injury and need only be considered if there were fever, lymphocytosis, presence of immunodeficiency, or use of immunosuppressive drugs. Other conditions that are perhaps more important to be excluded under Group II include acute exacerbation of chronic hepatitis B, C or D; acute onset or sudden exacerbation of autoimmune hepatitis, primary biliary cirrhosis (PBC) or sclerosing cholangitis (PSC); acute worsening of nonalcoholic fatty liver disease; acute hepatitis E; Wilson disease; sinusoidal obstruction syndrome; graft-vs-host disease; portal or hepatic vein thrombosis; cancerous replacement of the liver; and idiopathic acute liver failure. Many of these diagnoses are difficult if not impossible to exclude except with testing for specific serological markers (ANA for autoimmune hepatitis, AMA for PBC), specialized virological testing (hepatitis E), further follow up and history (cancer, worsening of nonalcoholic fatty liver disease, autoimmune hepatitis), liver biopsy (Wilson disease, sinusoidal obstruction syndrome, graft-vs-host disease, sclerosing cholangitis) or other specialized testing (imaging for hepatic or portal vein thrombosis, MRCP or ERCP for PSC, or serial testing for HBV DNA or HCV RNA to exclude acute exacerbations of chronic hepatitis B or C). Thus, cases of drug induced liver disease are generally given points for this category, unless there is strong suspicion of another diagnosis or ancillary testing was not done.

6. Previous Information on Hepatotoxicity of the Drug. The sixth category in the RUCAM system assigns points based upon known or published information about the agent’s potential to cause drug induced liver injury. For this category as well, points are given regardless of whether the injury is hepatocellular, mixed or cholestatic. Two points are given if the agent is stated to be a potential cause of drug induced liver disease in the product label; 1 point if the product is not labeled as such, but cases of liver injury from the agent have been published; and 0 points if the reaction is unknown to occur with the agent. This score is particularly difficult to assign as the product labels of drugs are difficult to find and are not always reliable. Furthermore, only rare drugs have never been mentioned as possibly hepatotoxins in the literature and experts in hepatotoxicity are likely to disagree about the relative hepatotoxicity potential of many medications. Furthermore, many drugs have been associated with occasional, mild and asymptomatic elevations in serum enzymes during treatment, but have not been linked to cases of clinically apparent liver injury. For these reasons, this category is usually given a fairly subjective interpretation.

7. Response to Readministration. Deliberate rechallenge with an agent believed to have caused drug induced liver injury provides convincing evidence for causality, but rarely is done. Inadvertent reexposure occasionally occurs when a patient, without understanding the implications, restarts a medication or another physician, unaware of a previous episode, prescribes the offending agent again. In these situations or with deliberate rechallenge, 3 points are assigned if there is a doubling of the ALT (in hepatocellular cases) or either the Alk P or total bilirubin doubles (in mixed or cholestatic cases) with the drug alone. One point is given if the drug is reintroduced during the acute injury and there is a doubling of the ALT, Alk P or bilirubin. Minus two (-2) points are assigned if there is no increase in ALT, Alk P or bilirubin to above the upper limit of normal with reexposure to the agent after recovery from the initial injury. No points ( 0 ) are given in the absence of rechallenge or reexposure.

Interpretation of rechallenge is often difficult. For instance, would doubling of a value that remains in the normal range (ALT from 15 to 30 U/L, Alk P from 45 to 100 U/L, or bilirubin from 0.4 to 0.8 mg/dL) be considered a positive rechallenge? Furthermore, the time of assessment after challenge, the duration and dose of rechallenge, and the frequency and timing of testing may be important and are not defined in the RUCAM system. Nevertheless, this category is usually not difficult to assign, because rechallenge is uncommon and the results of rechallenge are often clear.

The RUCAM is often tested against other means of assessing causality, but without strict adherence to consistent criteria on how it should be completed; it is not helpful to analyze intra- or inter-observer variation.

## Selected References

Danan G, Benichou C. (1993). Causality assessment of adverse reactions to drugs-I. A novel method based on the conclusions of International Consensus Meeting: application to drug-induced liver injuries. J Clin Epidemiol. (Description of the RUCAM System, based upon the results of Consensus Meetings of experts organized by Roussel Uclaf Pharmaceuticals on adverse events, liver events being representative; experts included Drs. Benhamou, Bircher, Dana, Maddrey, Neuberger, Orlani, Tygstrup and Zimmerman. R values were used to define cholestatic, hepatocellular and mixed. Time to onset given only 1+ or 2+, course given range of -3 to +3, risk factors 2 points [age, alcohol, pregnancy], other causes to include drugs and other diseases, previous knowledge of toxicity 0, 1+ or 2+, and rechallenge result -3 to +3. Discrepancy exists between Figures 1 and 2 regarding criterion 1 [0 to 3+ vs 1+ or 2+]. Using RUCAM, scores usually agreed, only 16% were more than 1 point different).
Benichou C, Danan G, Flahault A. (1993). Causality assessment of adverse reactions to drugs-II. An original model for validation of drug causality assessment methods: case reports with positive rechallenge. J Clin Epidemiol. (Results of using RUCAM on 77 case reports, single agent in 49; scores ranged from -5 to +13 [potential -5 to +14], introduced the terms “excluded” for scores of <0, “unlikely” for 1 to 2, “possible” for 3 to 5, “probable” for 6 to 8, and “highly probable” for >8).